# Antihypertensive Agents

## OVERVIEW

Antihypertensive medications are some of the most important and commonly used drugs in medical practice. Hypertension affects at least 50% of persons over the age of 60 and is an important cause of morbidity and mortality from cardiovascular and cerebrovascular disease.

More than 50 medications are used in the therapy of hypertension. The drugs can be categorized into seven major classes: (1) diuretics, (2) sympatholytic drugs, (3) calcium channel blockers, (4) angiotensin converting enzyme [ACE] inhibitors, (5) angiotensin II receptor antagonists/blockers [ARBs], (6) direct renin antagonists, and (7) various vasodilators.

Overall, the antihypertensive agents are rare causes of drug induced liver injury, the exceptions being two agents that have been in use for more than 50 years and are now not commonly used: methyldopa and hydralazine. The other antihypertensive drugs have been linked to drug induced liver injury only in isolated case reports and are rarely listed in large case series of acute liver failure or clinically apparent liver injury with jaundice due to medications.

The diuretics can be categorized into four groups: thiazides, loop diuretics, potassium-sparing diuretics, and carbonic anhydrase inhibitors. Some of these agents have been implicated in causing liver injury in rare single case reports.

1 Thiazide Diuretics
2 Loop Diuretics
3 Potassium-Sparing Diuretics
4 Carbonic Anhydrase Inhibitors

Sympatholytic drugs include alpha- and beta-adrenergic receptor antagonists (alpha blockers and beta blockers) as well as centrally acting agents such as clonidine, guanabenz, methyldopa, minoxidil, and reserpine. These agents rarely cause liver injury, the exception being methyldopa which can cause acute or chronic hepatitis, that can be severe, resulting in acute liver failure or cirrhosis.

- Alpha Adrenergic Receptor Antagonists
- Beta Adrenergic Receptor Antagonists
- Clonidine
- Methyldopa
- Reserpine

Calcium channel blockers (CCBs), angiotensin-converting enzyme (ACE) inhibitors, angiotensin receptor blockers (ARBs), and direct renin inhibitors are some of the most potent and well tolerated antihypertensive agents and are widely used. Many of these agents have been implicated in causing clinically apparent liver injury, but only in isolated case reports.

- Aliskiren
- Angiotensin-Converting Enzyme Inhibitors
- Angiotensin II Receptor Antagonists
- Calcium Channel Blockers

Finally, various arterial and venous vasodilators are useful for managing hypertension in special situations. Guanfacine, minoxidil and nitroprusside have not been implicated in causing liver injury. In contrast, hydralazine is a well known cause of clinically apparent liver injury, often presenting with autoimmune features.

- Guanfacine
- Hydralazine
- Minoxidil
- Sodium Nitroprusside

Heart Failure Agent

- Sacubitril-Valsartan

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2017

Zimmerman HJ. Antihypertensive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd edition. Philadelphia: Lippincott Williams & Wilkins, 1999. p. 654-60. (Expert review of drug induced liver injury due to antihypertensive agents published in 1999 discusses captopril, hydralazine and methyldopa).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-5. (Review of hepatotoxicity of antihypertensive agents discusses hydralazine, diuretics, ACE inhibitors, ARBs, beta blockers, calcium channel blockers and methyldopa).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics).
Drugs for hypertension. Treat Guidel Med Lett 2014; 12 (141): 31-8. (Concise summary recommendations for treatment of hypertension and current understanding of indications, efficacy and safety). 24759265
Drugs for hypertension. Med Lett Drugs Ther 2017; 59 (1516): 41-8. (Concise summary recommendations for treatment of hypertension and current understanding of indications, efficacy and safety). 28263286